# Noni

## OVERVIEW

### Introduction

Noni is a tropic fruit tree, the juice, roots, stems, bark, leaves and flowers of which have been used as medicinal remedies in Polynesia for centuries and recently in the Western world for a wide range of medical problems from cancer and diabetes to AIDs. A small number of isolated case reports of clinically apparent liver injury have been attributed to noni.

### Background

Morinda citrifolia is a small, tropic fruit tree commonly known as Indian Mulberry, Ba Ji Tian or Noni which has been used as a food and an herbal remedy for centuries in Polynesia and Southeast Asia. Recently, noni has been introduced into Western herbal medicine as a “tropic fruit with 101 medical uses”, and widely advertised and sold on the internet for a wide range of disorders including cancer, diabetes, depression, chronic fatigue, AIDS and senility. Active components in noni are many and include flavonoids, glycosides, vitamins, anthraquinones and polyunsaturated fatty acids. Studies in vitro and in animal models suggest that the active components are polysaccharide rich substances which have antitumor effects in vitro. In clinical trials, however, noni has yet to be proven to have anticancer activity. Noni juice has been marketed in the United States since 1996 and was approved as a “novel food” by the European Commission in 2003. While considered safe, several case reports of adverse events attributed to use of noni have appeared, although often criticized because of lack of chemical analysis of the actual product to exclude misidentification and contamination.

### Hepatotoxicity

Several case reports have suggested that noni may account for some cases of idiosyncratic acute liver injury, although the association was weak in many cases. The latency to onset ranged from 2 to 8 weeks and the clinical features resembled acute hepatitis with a hepatocellular pattern of serum enzyme elevations. Immunoallergic features (rash, fever, eosinophilia) were not present, but some patients had high levels of autoantibodies. Nevertheless, the liver injury resolved rapidly once noni was discontinued and other features of autoimmunity were not present.

Likelihood score: C (probable rare cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism of hepatotoxicity of noni is unknown. Extracts of the noni fruit have multiple components, including low levels of anthraquinones which are often cited as being hepatotoxic. However, the cases of noni associated liver injury have had all of the characteristics of idiosyncratic liver injury rather than direct toxicity, and in vitro and in vivo studies of noni have not demonstrated evidence of intrinsic hepatotoxicity.

### Outcome and Management

Hepatotoxicity attributed to noni juice has occasionally been severe and led to acute liver failure, which in at least one case necessitated emergency liver transplantation. Rechallenge studies have not been reported.

Other Names: Morinda citrifolia, Indian mulberry, Ba Ji Tian, Cheese fruit, Tahitian Noni Juice®, Xeronine

Drug Class: Herbal and Dietary Supplements

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Noni – Generic

DRUG CLASS

Herbal and Dietary Supplements

SUMMARY INFORMATION

Fact Sheet at National Center for Complementary and Integrative Health, NIH (https://www.nccih.nih.gov/health/noni)

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Noni | 84929-68-0 | Herbal mixture | Not applicable

## ANNOTATED BIBLIOGRAPHY

References updated: 28 March 2020

Zimmerman HJ. Unconventional drugs. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999: pp. 731-4. (Expert review of hepatotoxicity published in 1999; noni is not discussed).
Seeff L, Stickel F, Navarro VJ. Hepatotoxicity of herbals and dietary supplements. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 631-58. (Review of hepatotoxicity of herbal and dietary supplements [HDS] mentions that noni juice has been implicated in cases of hepatitis and acute liver failure).
Noni. In, PDR for Herbal Medicines. 4th ed. Montvale, New Jersey: Thomson Healthcare Inc. 2007, pp 604-5. (Compilation of short monographs on herbal medications and dietary supplements).
Wang MY, West BJ, Jensen CJ, Nowichi D, Su C, Palu AK, Anderson G. (2002). Morinda citrifolia(noni): a literature review and recent advances in Noni research. Acta Pharmacologica Sinica. (Extensive review of the literature on in vitro and in vivo effects of noni as well as studies in animals and humans which demonstrated lack of toxicity).
Pittler MH, Ernest E. (2003). Systematic review: hepatotoxic events associated with herbal medicinal products. Aliment Pharmacol Ther. (Systematic review of published cases of hepatotoxicity due to herbal medications listing 52 case reports or case series; noni is not listed or mentioned).
Millonig G, Stadlmann S, Vogel W. (2005). Herbal hepatotoxicity: acute hepatitis caused by a Noni preparation(Morinda citrifolia). Eur J Gastroenterol Hepatol. (45 year old man developed malaise and chest discomfort a few weeks after starting noni juice [bilirubin 0.8 mg/dL, ALT 1995 U/L, GGT 539 U/L], with resolution within 1 month of stopping).
Stadlbauer V, Fickert P, Lackner C, Schmerlaib J, Krisper P, Trauner M, Stauber RE. (2005). Hepatotoxicity of NONI juice: report of two cases. World J Gastroenterol. (2 cases from Austria: 29 year old man developed acute liver failure after taking 1.5 L of noni juice over 3 weeks and various Chinese herbs for 7 days [bilirubin 45.3 mg/dL, ALT 1626 U/L, INR 1.4], undergoing liver transplantation 6 days later; 62 year old woman developed vomiting and diarrhea 2 months after ingesting noni juice daily for 3 months [bilirubin 2.9 mg/dL, ALT 2381 U/L, Alk P 292 U/L], resolving over next 9 months).
West BJ, Jensen CJ, Westendorf J. (2006). Noni juice is not hepatotoxic. World J Gastroenterol. (Letter in response to Millonig [2005] and Stadlbauer [2005] questioning the link of the liver injury to noni juice intake, and reviewing studies of safety of noni in animals and man which showed no evidence of direct hepatotoxicity).
Yuce B, Gulberg V, Diebold J, Gerbes AL. (2006). Hepatitis induced by Noni juice from Morinda citrifolia: a rare cause of hepatotoxicity or the tip of the iceberg?. Digestion. (24 year old woman with multiple sclerosis on beta interferon developed jaundice 4 weeks after starting noni juice [bilirubin 5.3 rising to 43.5 mg/dL, ALT 1538 to 3648 U/L, GGT 110 U/L], resolving in 4 weeks after stopping noni and 5 weeks after stopping beta interferon).
West BJ. (2006). Hepatotoxicity from interferon-beta, not noni juice. Digestion. (Letter in response to Yuce [2006] suggesting that the liver injury was more likely due to beta interferon than noni).
López-Cepero Andrada JM, Lerma Castilla S, Fernández Olvera MD, Amaya Vidal A. (2007). Rev Esp Enferm Dig. (33 year old woman developed jaundice a few weeks after starting daily use of noni juice during travel to Ecuador [bilirubin 8.1 mg/dL, ALT 2740 U/L, Alk P 205 U/L, prothrombin 58%], resolving rapidly upon stopping the herbal).
West BJ, Berrio LF. (2007). Rev Esp Enferm Dig. (Letter in response to Lopez-Cepero Andrada [2007] questioning the role of noni juice in the liver injury, because of the lack of anti-HEV testing and lack of verification of the purity and identity of noni in the product).
Potterat O, Hamburger M. (2007). Morinda citrifolia(Noni) fruit—phytochemistry, pharmacology, safety. Planta Med. (Review of the history, phytochemistry, pharmacology, animal and clinical studies and safety of noni; 4 case reports of hepatotoxicity have been reported, but review by the European Food Safety Authority “concluded that there was no convincing evidence for a causal relationship”).
García-Cortés M, Borraz Y, Lucena MI, Peláez G, Salmerón J, Diago M, Martínez-Sierra MC, et al. (2008). Liver injury induced by “natural remedies”: an analysis of cases submitted to the Spanish Liver Toxicity Registry. Rev Esp Enferm Dig. (Among 521 cases of drug induced liver injury submitted to Spanish registry, 13 [2%] were due to herbals, but none were attributed to noni juice).
Stadlbauer V, Weiss S, Payer F, Stauber RE. (2008). Herbal does not at all mean innocuous: the sixth case of hepatotoxicity associated with morinda citrifolia(noni). Am J Gastroenterol. (43 year old man with glioblastoma developed elevated liver tests two weeks after starting noni juice [ALT rising from 34 to 516 U/L with normal bilirubin], resolving when noni juice was stopped).
West BJ, Su CX, Jensen CJ. (2009). Hepatotoxicity and subchronic toxicity tests of Morinda citrifolia(noni) fruit. J Toxicol Sci. (Noni extract was prepared from Tahitian noni fruits and tested for hepatotoxicity in vitro and in vivo; no toxicity found towards HepG2 cells or laboratory rats given a range of doses orally for up to 90 days).
Jacobsson I, Jönsson AK, Gerdén B, Hägg S. (2009). Spontaneously reported adverse reactions in association with complementary and alternative medicine substances in Sweden. Pharmacoepidemiol Drug Saf. (Review of 778 spontaneous reports of adverse reactions to herbals to Swedish Registry; noni juice not mentioned).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 [11%] were attributed to drug induced liver injury of which 12 [9%] were due to herbals, but none were attributed to noni juice).
Stickel F, Kessebohm K, Weimann R, Seitz HK. (2011). Review of liver injury associated with dietary supplements. Liver Int. (Review of current understanding of liver injury from herbals and dietary supplements focusing upon Herbalife and Hydroxycut products, green tea, usnic acid, Noni juice, Chinese herbs, vitamin A and anabolic steroids).
Yu EL, Sivagnanam M, Ellis L, Huang JS. (2011). Acute hepatotoxicity after ingestion of Morinda citrifolia (Noni Berry) juice in a 14-year-old boy. J Pediatr Gastroenterol Nutr. (14 year old boy developed jaundice after having ingested 10 bottles of an antioxidant drink [containing green tea, aloe vera and noni] over the previous 2 months [bilirubin 4.4 rising to 12.3 mg/dL, ALT 2860 U/L, GGT 141 U/L, INR 1.7], resolving in 2 months).
Jiménez-Encarnación E, Ríos G, Muñoz-Mirabal A, Vilá LM. Euforia-induced acute hepatitis in a patient with scleroderma. BMJ Case Rep 2012; 2012. (45 year old woman with systemic sclerosis developed jaundice 1 month after starting Euphoria, a combination herbal product whose ingredients included aloe vera, resveratrol, green tea, noni and several berries [bilirubin 17.7 mg/dL, ALT 837 U/L, Alk P 134 U/L], with slow recovery over the 18 months after stopping).
Teschke R, Wolff A, Frenzel C, Schulze J, Eickhoff A. (2012). Herbal hepatotoxicity: a tabular compilation of reported cases. Liver Int. (A systematic compilation of all publications on the hepatotoxicity of specific herbals identified 185 publications on 60 different herbs, herbal drugs and supplements including 6 publications on noni).
Teschke R, Schulze J, Schwarzenboeck A, Eickhoff A, Frenzel C. (2013). Herbal hepatotoxicity: suspected cases assessed for alternative causes. Eur J Gastroenterol Hepatol. (Review of 23 publications of case series of liver injury attributed to herbals or dietary supplements found alternative causes to be "evident" in 49% of 573 cases).
Bunchorntavakul C, Reddy KR. (2013). Review article: herbal and dietary supplement hepatotoxicity. Aliment Pharmacol Ther. (Systematic review of literature on HDS associated liver injury mentions that noni has been associated with clinically apparent hepatotoxicity).
Mrzljak A, Kosuta I, Skrtic A, Kanizaj TF, Vrhovac R. (2013). Drug-Induced Liver Injury Associated with Noni (Morinda citrifolia) Juice and Phenobarbital. Case Rep Gastroenterol. (38 year old woman on phenobarbital for 9 months developed jaundice one week after starting noni juice [60 mL daily] [bilirubin 9.7 mg/dL, ALT 813 U/L, Alk P 532 U/L, INR 2.6], resolving within 6 months of stopping both noni and phenobarbital and with corticosteroid therapy).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, including 15 [16%] due to herbal and dietary supplements, none of which were attributed to noni juice).
Navarro VJ, Seeff LB. (2013). Liver injury induced by herbal complementary and alternative medicine. Clin Liver Dis. (Review of HDS induced liver injury including regulatory problems, difficulties in diagnosis and causality assessment; mentions that noni has been linked to cases of hepatitis but none were fatal).
Navarro VJ, Barnhart H, Bonkovsky HL, Davern T, Fontana RJ, Grant L, Reddy KR, et al. (2014). Liver injury from herbals and dietary supplements in the U.S. Drug-Induced Liver Injury Network. Hepatology. (Among 85 cases of HDS associated liver injury [not due to anabolic steroids] enrolled in a US prospective study between 2004 and 2013, noni juice was not implicated in any of the cases).
Seeff LB, Bonkovsky HL, Navarro VJ, Wang G. (2015). Herbal products and the liver: a review of adverse effects and mechanisms. Gastroenterology. (Extensive review of possible beneficial as well as harmful effects of herbal products on the liver in a supplemental table lists noni as having been implicated in cases of severe acute hepatitis).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a prospective database between 2004 and 2012, HDS were implicated in 145 [16%], none of which were attributed to noni [Navarro et al Hepatology 2014]).
Garrido-Gallego F, Muñoz-Gómez R, Muñoz-Codoceo C, Delgado-Álvarez P, Fernández-Vázquez I, Castellano G. (2015). Acute liver failure in a patient consuming Herbalife products and Noni juice. Rev Esp Enferm Dig. (56 year old woman developed jaundice while taking several Herbalife products and noni juice [bilirubin 21.5 mg/dL, ALT 940 U/L, Alk P 187 U/L, INR 2.03], with progressive liver failure and successful liver transplantation 4 weeks after presentation).
García-Cortés M, Robles-Díaz M, Ortega-Alonso A, Medina-Caliz I, Andrade RJ. (2016). Hepatotoxicity by dietary supplements: A tabular listing and clinical characteristics. Int J Mol Sci. (Listing of published cases of liver injury from HDS products, but does not list those attributed to noni).
Brown AC. Liver toxicity related to herbs and dietary supplements: Online table of case reports. Part 2 of 5 series. Food Chem Toxicol 2017; 107 (Pt A): 472-501. (Description of an online compendium of cases of liver toxicity attributed to HDS products, lists at least 8 reports of liver injury for which there was exposure to noni; however, many had other possible causes).
Vega M, Verma M, Beswick D, Bey S, Hossack J, Merriman N, Shah A, et al., Drug Induced Liver Injury Network (DILIN). (2017). The incidence of drug- and herbal and dietary supplement-induced liver injury: preliminary findings from gastroenterologist-based surveillance in the population of the State of Delaware. Drug Saf. (A prospective, population based registry of cases of drug induced liver injury occurring in Delaware during 2014, identified 20 cases [2.7 per 100,000] overall, including 6 due to HDS products, all of which were proprietary multiingredient products, none specifically listing noni as a component).
Waldman W, Piotrowicz G, Sein Anand J. (2013). Przegl Lek. (Ordered).

## OTHER REFERENCE LINKS

1 Recent References on Noni: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Noni+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Noni: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Noni)